# Lazertinib

## OVERVIEW

### Introduction

Lazertinib is a small molecule inhibitor of the epidermal growth factor (EGF) receptor that is used in combination with amivantamab to treat adults with locally advanced or metastatic non-small cell lung cancer that harbors EGF receptor mutations. The combination of lazertinib and amivantamab is associated with transient elevations in serum aminotransferase levels during therapy but has not been linked to episodes of clinically apparent liver injury with jaundice.

### Background

Lazertinib (laz’ er tin ib) is an orally available, specific inhibitor of the epidermal growth factor (EGF) receptor that is used in combination with amivantamab in the therapy of advanced or metastatic non-small cell lung cancer (NSCLC) with EGF receptor mutations. EGF receptors are frequently mutated in lung cancer and can account for drug resistance using conventional EGF receptor inhibitors. Lazertinib has activity against wild type EGF receptors and has potent activity against receptors that harbor exon 19 deletions and exon 21 L858R, which are found in 10% to 15% of patients diagnosed with NSCLC. In a large, controlled trial, lazertinib in combination with amivantamab (a bispecific monoclonal antibody to the EGF receptor and MET) was compared to the current standard EGF receptor kinase inhibitor (osimertinib) for patients with advanced or metastatic NSCLC. The median progression-free survival was superior with the combination (23.7 months) compared to osimertinib (16.6 months). Lazertinib in combination with amivantamab was approved as a first line treatment for patients with metastatic NSCLC harboring mutations of exon 19 deletions or exon 21 L858R in 2024. Lazertinib is available in tablets of 80 and 240 mg under the brand name Lazcluze. The recommended dose is 240 mg once daily in combination with amivantamab (brand name Rybrevant) given intravenously once weekly for 4 weeks followed by every 3 weeks until unacceptable intolerance or disease progression arises. Side effects are common with lazertinib and amivantamab combination therapy. Common, mild-to-moderate side effects include rash, nail toxicity, infusion related reactions, fatigue, stomatitis, nausea, diarrhea, constipation, decreased appetite, edema, musculoskeletal pain, paresthesia, pruritus, and abdominal pain. Less frequent but potentially severe adverse events include severe infusion related reactions, interstitial lung disease, venous thromboembolic events, severe skin rash, ocular toxicity and embryo-fetal toxicity. The combination has a boxed warning about thromboembolic events and routine anticoagulation is recommended for the first 4 months of treatment.

### Hepatotoxicity

In the prelicensure trial of the combination of lazertinib and amivantamab, liver test abnormalities were frequent, with elevations in ALT of 65%, AST 65%, and GGT 39% but without bilirubin elevations. The enzyme elevations were usually transient, mild-to-moderate in severity and not associated with symptoms or jaundice. ALT elevations above 5 times the upper limit of normal (ULN) arose in 7% of subjects and were self-limited in course and not associated with jaundice. The ALT elevations led to dose interruptions in 6% of patients but not to drug discontinuations. Some of the aminotransferase elevations may have been due to amivantamab rather than lazertinib or even to the anticoagulants that are used during the first 4 months of therapy. There were no deaths or episodes of life threatening liver injury among the 421 patients receiving combination therapy in the preregistration safety cohort. Since approval and more widespread use of lazertinib and amivantamab, there have been no published case reports of clinically apparent liver injury with jaundice. Nevertheless, several instances of severe and even fatal liver injury have been linked to use of other EGF kinase inhibitors such as afatinib, erlotinib, and gefitinib.

Likelihood score: E* (unproven but suspected rare cause of clinically apparent liver injury).

### Mechanism of Injury

The causes of serum enzyme elevations or liver injury from lazertinib therapy are probably the result of direct toxicity of the multi-kinase receptor inhibition. Lazertinib is metabolized in the liver largely via the CYP 3A4 pathway, and liver injury might also be caused by production of a toxic or immunogenic intermediate of its metabolism. Because it is a substrate for CYP 3A4, lazertinib is susceptible to drug-drug interactions with agents that inhibit or induce this specific hepatic microsomal activity.

### Outcome and Management

The product label for lazertinib recommends monitoring of liver tests before initiating therapy and frequently during treatment. Serum aminotransferase elevations above 5 times the upper limit of normal (if confirmed) or any elevations accompanied by jaundice or symptoms should lead to at least temporary cessation. There is no evidence to suggest a cross reactivity in risk for adverse events, hypersensitivity, or hepatic injury between lazertinib and other EGF receptor inhibitors such as afatinib, mobocertinib, or osimertinib.

Drug Class: Antineoplastic Agents, Protein Kinase Inhibitors

Other EGF Receptor Targeted Kinase Inhibitors Used to Treat NSCLC: Axitinib, Erlotinib, Gefitinib, Mobocertinib, Osimertinib

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Lazertinib – Lazcluze®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Lazertinib)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Lazertinib | 1903008-80-9 | C30-H34-N8-O3

## ANNOTATED BIBLIOGRAPHY

References updated: 23 March 2025

Abbreviations: EGF, epidermal growth factor; ULN, upper limit of the normal range.

Zimmerman HJ. Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of tyrosine kinase inhibitors such as lazertinib).
DeLeve LD. Erlotinib. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 556. (Review of hepatotoxicity of cancer chemotherapeutic agents discusses several tyrosine kinase inhibitors including imatinib, gefitinib, erlotinib and crizotinib, but not lazertinib).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Pathway-targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics).
FDA. Multi-Discipline Review. 2024. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2024/219008Orig1s000MultidisciplineR.pdf (FDA review of the data on efficacy and safety of lazertinib in support of its approval for first line therapy of NSCLC when given in combination with amivantamab in the US, mentions that liver test abnormalities were frequent in the 421 patients treated, ALT elevations arising in 65% of lazertinib treated subjects which were above 5 times the upper limit of normal (ULN) in 7%, leading to dose interruptions in 6%, but there were no discontinuations for serum enzyme elevations, and no instances of clinically apparent liver injury).
Spraggs CF, Xu CF, Hunt CM. Genetic characterization to improve interpretation and clinical management of hepatotoxicity caused by tyrosine kinase inhibitors. Pharmacogenomics 2013; 14: 541-54. (Review of genetic associations of serum ALT and bilirubin elevations during therapy with tyrosine kinase inhibitors focusing on lapatinib and pazopanib; lazertinib is not discussed). 23556451
Shah RR, Morganroth J, Shah DR. Hepatotoxicity of tyrosine kinase inhibitors: clinical and regulatory perspectives. Drug Saf 2013; 36: 491-503. (Review of the hepatotoxicity of 18 tyrosine kinase inhibitors approved for use in cancer in the US as of 2013, before the availability of lazertinib which is not discussed). 23620168
Cho BC, Ahn MJ, Kang JH, Soo RA, Reungwetwattana T, Yang JC, Cicin I, et al. Lazertinib versus gefitinib as first-line treatment in patients with EGFR-mutated advanced non-small-cell lung cancer: Results from LASER301. J Clin Oncol. 2023;41:4208-4217. (Among 393 patients with advanced NSCLC treated with lazertinib [240 mg daily] without amivantamab vs gefitinib [250 mg daily] as first line therapy [without previous kinase inhibitor treatment], the median progression-free survival was 20.6 vs 9.7 months, and while overall adverse event rates were similar [96% vs 95%], ALT and AST elevations were fewer with lazertinib [15% vs 30% and 11% vs 26%]). 37379502
Passaro A, Wang J, Wang Y, Lee SH, Melosky B, Shih JY, Wang J, et al.; MARIPOSA-2 Investigators. Amivantamab plus chemotherapy with and without lazertinib in EGFR-mutant advanced NSCLC after disease progression on osimertinib: primary results from the phase III MARIPOSA-2 study. Ann Oncol. 2024;35:77-90. (Among 657 patients with EGF receptor mutant, advanced NSCLC refractory of osimertinib who were treated with amivantamab and standard chemotherapy with or without lazertinib or placebo, progression-free survival was highest with amivantamab combined with lazertinib [8.3 months] vs amivantamab and chemotherapy [6.3 months] and chemotherapy alone [4.2 months], but so were serious adverse events [57% vs 32% vs 20%], but rates of ALT elevations were similar [21% vs 20% vs 28%] including elevations above 5 times ULN [5% vs 5% vs 4%], and there were no reports of liver injury with jaundice). 37879444
Chul Cho B, Han JY, Hyeong Lee K, Lee YG, Kim DW, Joo Min Y, Kim SW, et al. Lazertinib as a frontline treatment in patients with EGFR-mutated advanced non-small cell lung cancer: long-term follow-up results from LASER201. Lung Cancer. 2024;190:107509. (Among 43 patients with advanced NSCLC treated with lazertinib [240 mg daily] without amivantamab as first line therapy [without previous kinase inhibitor treatment], the objective response rate was 70% and median progression-free survival 24.6 months, while adverse events occurred 100% and were severe in 37%, ALT elevations arising in 26% that were above 5 times ULN in 5%). 38432025
Leighl NB, Akamatsu H, Lim SM, Cheng Y, Minchom AR, Marmarelis ME, Sanborn RE, et al.; PALOMA-3 Investigators. Subcutaneous versus intravenous amivantamab, both in combination with lazertinib, in refractory epidermal growth factor receptor-mutated non-small cell lung cancer: primary results from the phase III PALOMA-3 study. J Clin Oncol. 2024;42:3593-3605. (Among 418 patients with refractory, EGF receptor mutated NSCLC treated with lazertinib and either subcutaneous or intravenous amivantamab, the objective response rate was similar while infusion related reactions were fewer with sc dosing [13% vs 66%] and therapy was in general better tolerated, ALT elevations arising in 20% vs 21% and were above 5 times ULN in 1% of both groups). 38857463
Lazertinib (Lazcluze) for non-small cell lung cancer. Med Lett Drugs Ther. 2024;66:e176-e177. (Concise review of the mechanism of action, clinical efficacy, safety, and costs of lazertinib shortly after its approval as therapy in combination with amivantamab in 2024, mentions the many side effects of combination therapy but does not mention ALT elevations or hepatotoxicity). 39466312
Cho BC, Lu S, Felip E, Spira AI, Girard N, Lee JS, Lee SH, et al.; MARIPOSA Investigators. Amivantamab plus lazertinib in previously untreated EGFR-mutated advanced NSCLC. N Engl J Med. 2024;391(16):1486-1498. (Among 1074 adults with advanced NSCLC harboring EGF receptor mutations [exon 19 deletion or L858R] treated with lazertinib with or without amivantamab vs osimertinib, progression-free survival was longer with the combination vs osimertinib [23.7 vs 16.6 months], while serious adverse events rates were higher [49% vs 33%] as were dose reductions [59% vs 5%], discontinuations [35% vs 14%] and ALT elevations [36% vs 13%], which were above 5 times ULN in 5% vs 2%] but there were no discontinuations for liver injury]. 38924756

## OTHER REFERENCE LINKS

1. Recent References on Lazertinib: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Lazertinib+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Lazertinib: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Lazertinib)